# Leukotriene Receptor Antagonists

## OVERVIEW

The leukotriene receptor antagonists are among the most prescribed drugs for the management of asthma, used both for treatment and prevention of acute asthmatic attacks. This class of drugs acts by binding to cysteinyl leukotriene (CysLT) receptors and blocking their activation and the subsequent inflammatory cascade which cause the symptoms commonly associated with asthma and allergic rhinitis.

The cysteinyl leukotrienes (C4, D4 and E4) are products of arachidonic acid metabolism and are released from various cells, including mast cells and eosinophils. These eicosanoids bind to CysLT receptors. The CysLT type-1 receptor is found in the human airway smooth muscle cells and airway macrophages and on other proinflammatory cells. In asthmatic patients, leukotriene mediated effects include airway edema, smooth muscle contraction, and altered cellular activity associated with the inflammatory process. In allergic rhinitis, CysLTs are released from the nasal mucosa after allergen exposure and precipitate the symptoms of allergic rhinitis.

Two leukotriene receptor antagonists are available in the United States, zafirlukast (1996) and montelukast (1998). Both are oral agents used in management of asthma and allergic rhinitis. Both have been associated with rare cases of acute liver injury. While they have similar mechanisms of action, these two agents are structurally distinct, and the liver injury they cause does not appear to be similar in pattern of presentation or outcome. Indeed, several instances of hepatotoxicity due to one agent have been described in which the patient has tolerated the other agent without recurrence. For this reason, these two agents are discussed separately.

The following links are to individual drug records.

- Montelukast
- Zafirlukast

Drug Class: Antiasthmatic Agents

Last updated: 06 June 2019